# Omalizumab

## OVERVIEW

### Introduction

Omalizumab is a monoclonal antibody to human immunoglobulin E (IgE), which leads to a decrease in IgE binding to mast cells and basophils and a reduction in allergic symptoms of asthma and seasonal rhinitis. Omalizumab therapy has not been associated with serum enzyme elevations during therapy and has yet to be implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Omalizumab (oh” ma liz’ ue mab) is a recombinant, human monoclonal antibody to IgE which binds avidly to circulating immunoglobulin E, preventing its attachment to high affinity receptors on mast cells and basophils. This receptor inhibition prevents the release of histamine and other mediators of the allergic immune response, reducing airway inflammation and spasm and alleviating symptoms of asthma and allergic rhinitis. Therapy with omalizumab has been shown to reduce the requirement for inhaled corticosteroids and lower the frequency of exacerbations of asthma and to decrease the severity and symptoms of chronic urticaria of unknown cause. Omalizumab was approved for use in the United States in 2003 for therapy of patients with severe and persistent asthma despite corticosteroid inhalation therapy. The indications were extended in 2014 to include chronic idiopathic urticaria and in later to include nasal polyps. Omalizumab has been evaluated in patients with seasonal rhinitis, but has yet to be approved for that use. Omalizumab is available in single use vials of 150 mg under the brand name Xolair. The recommended dose is 150 to 300 mg intravenously every 4 weeks or 225 to 375 mg every 2 weeks based upon body weight and IgE levels. Common side effects include injection site reactions, rash, diarrhea, nausea and vomiting, dizziness, fatigue and epistaxis. Rarely, omalizumab can cause serious acute anaphylaxis or anaphylactoid reactions (~0.1%) and should be given under close medical supervision.

### Hepatotoxicity

In large clinical trials, omalizumab was not associated with changes in serum aminotransferase levels during therapy, and rates of most adverse reactions were similar in patients who received omalizumab or placebo. There have been no published reports of clinically apparent acute liver injury attributed to omalizumab therapy. Thus, liver injury from omalizumab must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Omalizumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Omalizumab lowers serum levels of IgE, which seems to have no adverse effects on the liver and does not result in significant immunosuppression.

Drug Class: Antiasthmatic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omalizumab – Xolair®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Omalizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Omalizumab | 242138-07-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 December 2028

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; omalizumab is not specifically mentioned).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-48. (Textbook of pharmacology and therapeutics).
Milgrom H, Fick RB, Su JQ, Reimann JD, Bush RK, Watrous ML, Metzger WJ. (1999). Treatment of allergic asthma with monoclonal anti-IgE antibody. rhuMAb-E25 Study Group. N Engl J Med. (In a controlled trial of omalizumab vs placebo for 20 weeks in 317 patients with asthma, side effects were similar between the two groups; no mention of ALT elevations or hepatotoxicity).
Casale TB, Condemi J, LaForce C, Nayak A, Rowe M, Watrous M, McAlary M, et al., Omalizumab Seasonal Allergic Rhinitis Trial Group. (2001). Effect of omalizumab on symptoms of seasonal allergic rhinitis: a randomized controlled trial. JAMA. (A controlled trial of 3 doses of omalizumab versus placebo in 536 patients with allergic rhinitis reported no difference in adverse events between omalizumab and placebo therapy, and "there were no clinically significant alterations in laboratory values in either group").
Milgrom H, Berger W, Nayak A, Gupta N, Pollard S, McAlary M, Taylor AF, et al. (2001). Treatment of childhood asthma with anti-immunoglobulin E antibody(omalizumab). Pediatrics. (Controlled trial of omalizumab versus placebo in 536 patients with asthma for 4 months found similar rates of adverse events in the two groups).
Berger W, Gupta N, McAlary M, Fowler-Taylor A. (2003). Evaluation of long-term safety of the anti-IgE antibody, omalizumab, in children with allergic asthma. Ann Allergy Asthma Immunol. (Among 225 children with asthma treated with omalizumab for up to 52 weeks, "There were no clinically significant changes... in laboratory safety tests").
(2003). Omalizumab (Xolair): an anti-IgE antibody for asthma. Med Lett Drugs Ther. (Concise review of the efficacy and safety of omalizumab shortly after its approval for use in asthma in the US; no mention of ALT elevations or hepatotoxicity).
Ruffin CG, Busch BE. (2004). Omalizumab: a recombinant humanized anti-IgE antibody for allergic asthma. Am J Health Syst Pharm. (Overview of the chemistry, mechanisms of action, pharmacology, efficacy and safety of omalizumab as therapy of asthma states that the rate of common adverse effects is similar between omalizumab and placebo treated patients; no mention of ALT elevations or hepatotoxicity).
Strunk RC, Bloomberg GR. (2006). Omalizumab for asthma. N Engl J Med. (Review of the mechanism of action of omalizumab in asthma and studies of its efficacy and safety; no mention of ALT elevations or hepatotoxicity).
Antonicelli L, Stagnozzi G, Giuliodoro S, Abbruzzetti A, Massaccesi C. (2009). The safety of omalizumab therapy in a patient with severe persistent allergic asthma and hepatitis C. Ann Allergy Asthma Immunol. (Analysis of results from a single patient with chronic hepatitis C and severe asthma who received omalizumab for 19 months with a beneficial response and no change in serum ALT or HCV RNA levels).
Corren J, Casale TB, Lanier B, Buhl R, Holgate S, Jimenez P. (2009). Safety and tolerability of omalizumab. Clin Exp Allergy. (Review of the safety of omalizumab in 7500 patients controlled studies in asthma, allergic rhinitis and related conditions reported that overall and serious adverse event rates were similar between omalizumab and placebo groups, and that "There were no between-treatment-group differences ≥2% in the frequency of shifts from normal to abnormal in liver function tests").
Hanania NA, Alpan O, Hamilos DL, Condemi JJ, Reyes-Rivera I, Zhu J, Rosen KE, et al. (2011). Omalizumab in severe allergic asthma inadequately controlled with standard therapy: a randomized trial. Ann Intern Med. (Controlled trial of omalizumab versus placebo for 48 weeks in 850 patients with asthma found similar rates of serious adverse events and stated that "no clinically relevant abnormality of laboratory tests was observed").
Maurer M, Rosén K, Hsieh HJ, Saini S, Grattan C, Gimenéz-Arnau A, Agarwal S, et al. (2013). Omalizumab for the treatment of chronic idiopathic or spontaneous urticaria. N Engl J Med. (Controlled trial of 3 doses of omalizumab versus placebo for 16 weeks in 323 patients with chronic urticaria stated that "the frequency of adverse events were similar across groups"; ALT elevations and hepatotoxicity were not mentioned).
(2013). Drugs for asthma and COPD. Treat Guidel Med Lett. (Concise summary of guidelines for therapy of asthma mentions that omalizumab is approved for use in severe, persistent asthma; no mention of ALT elevations or hepatotoxicity).
Tsabouri S, Tseretopoulou X, Priftis K, Ntzani EE. (2014). Omalizumab for the treatment of inadequately controlled allergic rhinitis: a systematic review and meta-analysis of randomized clinical trials. J Allergy Clin Immunol Pract. (Systematic review of 11 controlled trials of omalizumab in 2870 patients with allergic rhinitis found no difference in rates of any adverse event between omalizumab and placebo; no specific discussion of ALT elevations or clinically apparent liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, the only antiasthma drug implicated was montelukast [4 cases: 0.5%]).
(2017). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including omalizumab side effects of which include injection site reactions, bruising and hypersensitivity reactions include anaphylaxis which can be life-threatening, for which reason it should be administered in a health care setting by medical staff training in treating anaphylaxis emergencies).
Chicharro P, Rodríguez-Jiménez P, de Argila D. (2017). Efficacy and safety of omalizumab in a patient with chronic spontaneous urticaria and active hepatitis B virus infection. Actas Dermosifiliogr. (56 year old woman with chronic urticaria and HBsAg in serum with HBV DNA 20,000 IU/mL but normal serum enzymes was treated with omalizumab, with rapid improvement in urticaria and no worsening of liver tests, HBV DNA falling to 627 IU/mL).
Menzella F, Galeone C, Formisano D, Castagnetti C, Ruggiero P, Simonazzi A, Zucchi L. (2017). Real-life efficacy of omalizumab after 9 years of follow-up. Allergy Asthma Immunol Res. (Among 8 adult patients with severe asthma with inadequate response to conventional therapy who were treated with omalizumab for 9 years, all had a sustained improvement in pulmonary function tests, decreased need for conventional medications and improved quality of life and there were “no changes in liver function parameters”).
Di Bona D, Fiorino I, Taurino M, Frisenda F, Minenna E, Pasculli C, Kourtis G, et al. (2017). Long-term "real-life" safety of omalizumab in patients with severe uncontrolled asthma: A nine-year study. Respir Med. (Among 91 patients with severe persistent asthma treated with omalizumab for up to 9 years [mean 3.8 years], side effects included arthralgias, myalgias, fatigue, recurrent herpes labialis and urticaria, only 6 patients stopping therapy because of side effects; no mention of ALT elevations or hepatotoxicity).
Bhutani M, Yang WH, Hébert J, de Takacsy F, Stril JL. (2017). The real world effect of omalizumab add on therapy for patients with moderate to severe allergic asthma: The ASTERIX Observational study. PLoS One. (Among 99 patients with severe persistent asthma treated with omalizumab for 52 weeks, asthma symptoms improved and 56 remained exacerbation free while adverse effects were usually mild, and of 9 severe adverse events only one was judged to be drug related [dizziness leading to discontinuation] and there were no reported liver related events).
Baan EJ, de Smet VA, Hoeve CE, Pacurariu AC, Sturkenboom MCJM, de Jongste JC, Janssens HM, et al. (2020). Exploratory study of signals for asthma drugs in children, using the eudraVigilance database of spontaneous reports. Drug Saf. (Review of the European drug adverse event vigilance database from 2011 to 2017 identified 21,364 reports in children and 172,035 for adults related to drugs for asthma, most commonly montelukast [n=2210], salbutamol [947] and omalizumab [690], some of which were considered new and not previously described; no discussion of liver related adverse events).
Gevaert P, Omachi TA, Corren J, Mullol J, Han J, Lee SE, Kaufman D, et al. (2020). Efficacy and safety of omalizumab in nasal polyposis: 2 randomized phase 3 trials. J Allergy Clin Immunol. (Among 265 patients with rhinosinusitis and nasal polyps enrolled in two randomized placebo controlled trials of omalizumab or placebo infusions every 4 weeks for 24 weeks, symptoms of nasal congestion and polyps improved with omalizumab therapy but not with placebo, while adverse event rates were similar in the two groups and there were no liver related severe adverse events; no mention of ALT elevations or hepatotoxicity).
Dekkers C, Alizadeh Aghdam M, Graaf M, Knulst AC, Meijer Y, van den Reek JMPA, Stadermann MB, Röckmann H. (2020). Safety and effectiveness of omalizumab for the treatment of chronic urticaria in pediatric patients. Pediatr Allergy Immunol. (Among 38 children with chronic urticaria treated with omalizumab for up to two years, a clinical response was achieved in 76%, while only 12 children [32%] had mostly mild side effects, including headache, fatigue, injection site reactions, upper respiratory symptoms, arthralgias, hair loss and loss of concentration [which accounted for the only adverse event related discontinuation]; no mention of ALT elevations or hepatotoxicity).
(2020). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including monoclonal antibodies to IgE, IL5, and the IL5 and IL4 receptors, which are used largely for eosinophilic asthma that has not responded adequately to conventional medications; mentions that zileuton and zafirlukast have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended whereas discussions of the other anti-asthma medications do not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Omalizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Omalizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Omalizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Omalizumab)